# Floxuridine

## OVERVIEW

### Introduction

Floxuridine (FUDR) is a pyrimidine analogue used as an antineoplastic agent, usually as a continuous hepatic arterial infusion to treat hepatic metastases from colon cancer. Intraarterial floxuridine is associated with a very high rate of serum enzyme and bilirubin elevations during therapy, and with frequent biliary damage that can result in a secondary sclerosing cholangitis, which can be severe and lead to cirrhosis.

### Background

Floxuridine (flox ure' i deen) is a fluoropyrimidine (fluorodeoxyuridine; FUDR) that has antineoplastic action against several solid tumors including liver, gastrointestinal adenocarcinoma and colorectal cancers. Floxuridine, like fluorouracil, requires conversion to monophosphate and possibly the triphosphate. It appears to act by inhibition of production or direct competition with thymidine triphosphate, which is necessary for DNA synthesis. Floxuridine was approved for use as an anticancer agent in the United States in 1970 and is given predominantly by continuous infusion into the hepatic artery to treat metastatic carcinoma of the colon or following resection of colon cancer metastases. Floxuridine is available as a powder for reconstitution in 500 mg vials (5 mL, 100 mg/mL) in several generic forms. Floxuridine is typically given by infusion pump into the hepatic artery in a dose of 0.1 to 0.6 mg/kg/day. Because the liver metabolizes floxuridine, administration by direct infusion into the hepatic artery deceases the systemic side effects which can be severe. Common side effects of intraarterial therapy include bone marrow suppression, fatigue, weakness, headache, dizziness, insomnia, paresthesias, abdominal pain, constipation, diarrhea, dyspepsia, nausea, stomatitis, and rash.

### Hepatotoxicity

Serum aminotransferase elevations occur in a high proportion of patients given floxuridine by infusion into the hepatic artery, the reported rates ranging from 25% to 100%. These elevations are generally mild to moderate in severity and resolve with stopping therapy. "Chemical hepatitis," however, not infrequently is a cause of dose modification or delay in cycles of treatment. In addition, prolonged or repeated hepatic arterial infusions of FUDR can cause acalculous cholecystitis and multiple biliary strictures that can cause jaundice and a chronic sclerosing cholangitis-like syndrome. Between 5% and 25% of patients treated with hepatic arterial infusions of FUDR will develop symptomatic biliary strictures with pain and jaundice. These typically arise after 2 to 6 months of therapy, but can appear later, even more than a year after initiating FUDR therapy. The biliary strictures typically affect central bile ducts in the area of the porta hepatis, generally in and around the bifurcation of the common hepatic duct. Similar inflammation and fibrosis account for the acalculous cholecystitis that can occur with FUDR therapy, but which can be avoided by cholecystectomy at the time of hepatic resection of metastases or placement of the intraarterial infusion pump. The biliary strictures generally improve with stopping therapy, but can progress or require endoscopic or surgical intervention. Deaths from progressive biliary strictures and cholestatic liver injury have been described and can be a major cause of death among survivors of this metastatic tumor. The frequency of biliary strictures after FUDR therapy may be decreased by concurrent administration of dexamethasone and avoided by monitoring with hepatic and biliary imaging. However, the many complications of hepatic arterial infusion chemotherapy have decreased enthusiasm for this therapy, particularly with newer, more potent systemic antineoplastic agents.

Likelihood score: A (well known cause of clinically apparent liver and biliary injury).

### Mechanism of Injury

FUDR can cause both hepatocellular (chemical hepatitis) and cholestatic (biliary strictures, cholangitis) injury. Both appear to be the direct, intrinsic toxicity of FUDR. In a dog animal model, the biliary injury can be reproduced with hepatic artery infusions and the hepatocellular injury (without bile duct damage) by portal vein infusions of FUDR.

### Outcome and Management

The severity of the liver injury linked to floxuridine therapy ranges from minimal and transient serum enzyme elevations to severe cholestatic liver injury due to severe biliary strictures. Hepatic injury arising during FUDR therapy is a frequent reason for dose modification or delay in cycles of therapy. Appearance of jaundice due to hepatic arterial infusions of FUDR should lead to its discontinuation, as further therapy usually worsens the course. If the infusions are discontinued early, partial recovery with resolution of jaundice and symptoms is not uncommon. There is little evidence for cross sensitivity to hepatic injury among the various pyrimidine analogue antineoplastic agents. However, hepatic toxicity between floxuridine and fluorouracil can be additive.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Pyrimidine Analogues: Azacitidine, Capecitabine, Cytarabine, Decitabine, Fluorouracil, Gemcitabine, Trifluridine/Tipracil

## CASE REPORT

### Case 1. Sclerosing cholangitis due to intrahepatic infusions of floxuridine.

[Modified from: Ludwig J, Kim CH, Wiesner RH, Krom RA. Floxuridine-induced sclerosing cholangitis: an ischemic cholangiopathy? Hepatology 1989; 9: 215-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/2521475)]

A 43 year old man was found to have a single hepatic metastasis 10 months after resection of a rectal adenocarcinoma. He underwent left hepatic lobectomy and placement of a subcutaneous infusion pump with a catheter in the common hepatic artery for adjuvant chemotherapy. Continuous intraarterial infusions of floxuridine [0.3 mg per kg per day for 2 weeks each month] were started. Because of liver test abnormalities, treatment was discontinued intermittently with subsequent improvement. After 21 months of treatment and 15 courses (total dose of 4.725 g), however, he developed persistent jaundice and pruritus. Serum bilirubin was 17.1 mg/dL, ALT 128 U/L and alkaline phosphatase 630 U/L. Values had been normal before therapy (Table). Endoscopic retrograde cholangiopancreatography showed strictures in the common bile duct. A liver biopsy revealed cholestatic hepatitis, paucity of intrahepatic bile ducts and marked periductular fibrosis. Therapy was discontinued, but he continued to worsen. A trial of prednisolone was unsuccessful. Within 6 months, he had developed signs of hepatic failure with ascites and intractable pruritus. He had no evidence of cancer recurrence, was placed on a liver transplant list and underwent successful orthotopic liver transplantation 2.5 years after starting chemotherapy.

#### Key Points

Medication: | Floxuridine(by hepatic artery infusion)
Pattern: | Cholestatic (R=1.5)
Severity: | 4+ (progression to cirrhosis)
Latency: | 21 months
Recovery: | Incomplete
Other medications: | Not mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 24 | 175 | 0.9 | Before therapy
0 | Pre | Started chemotherapy with hepatic arterial infusions of FUDR
6 months | Pre | 118 | 485 | 7.1 | Therapy held transiently
21 months | 0 | 128 | 630 | 17.1 | Therapy permanently stopped
26 months | 5 months | 150 | 1206 | 29.2
32 months | 11 months | 190 | 1242 | 21.2 | Liver transplantation
Normal Values | | <32 | <239 | <1.2

#### Comment

Careful analysis of the explants at the time of liver transplantation showed no evidence of tumor recurrence. The liver was enlarged and the porta hepatis was scarred and difficult to dissect. Histologically there was obstructive arteriopathy and venopathy with partial occlusion of portal arterioles and venules. Bile ducts were obliterated and the periphery of the liver showed paucity of small bile ducts. Thus, the primary lesion was considered to be ischemic damage to bile ducts of the porta hepatis causing sclerosis, loss of intrahepatic ducts, obstructive jaundice and a secondary biliary cirrhosis.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Floxuridine – Generic

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Floxuridine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Floxuridine | 50-91-9 | C9-H11-F-N2-O5 | Floxuridine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 02 February 2018

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that pump intraarterial infusions of floxuridine (FUDR) cause a high rate of biochemical abnormalities and cause a sclerosing cholangitis-like syndrome in 5-100% of recipients, depending upon the dose and duration of therapy and the efforts made to identify the lesion).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rdd ed. Amsterdam: Elsevier, 2013, p. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents; mentions that floxuridine, when given as intrahepatic arterial infusion, can cause transient liver test abnormalities in 15-22% of patients and severe biliary sclerosis in 9%).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan D. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman.s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-730. (Textbook of pharmacology and therapeutics; FUDR is used primarily by continuous infusion into the hepatic artery for treatment of hepatic metastases).
Chabner BA, Myers CE, Coleman CN, Johns DG. The clinical pharmacology of antineoplastic agents (first of two parts). N Engl J Med 1975; 292: 1107-13. (Review of the pharmacology, metabolism and mechanism of action of methotrexate and fluorouracil). 124015
Stagg RJ, Lewis BJ, Friedman MA, Ignoffo RJ, Hohn DC. Hepatic arterial chemotherapy for colorectal cancer metastatic to the liver. Ann Intern Med 1984; 100: 736-43. (Review of the rationale, technique and efficacy of hepatic arterial chemotherapy for hepatic metastases of colorectal cancer, which was developed because of poor responses to systemic therapy; summarizing results in more than 1000 patients, including 445 given fluorouracil and 264 FUDR; little discussion of toxicity). 6231876
Daly JM, Kemeny N, Oderman P, Botet J. Long-term hepatic arterial infusion chemotherapy. Arch Surg 1984; 119: 935-41. (40 patients with metastatic colorectal cancer underwent hepatic arterial infusions with FUDR; toxic effects were largely gastrointestinal with ulcers [30%], gastritis without ulcers [18%], elevations in bilirubin >3 mg/dL [23%], AST [65%], and extrahepatic bile duct strictures [5%]). 6378147
Kemeny MM, Goldberg DA, Browning S, Metter GE, Miner PJ, Terz JJ. Experience with continuous regional chemotherapy and hepatic resection as treatment of hepatic metastases from colorectal primaries. A prospective randomized study. Cancer 1985; 55: 1265-70. (Among 46 patients with hepatic metastases from colorectal cancer treated with continuous hepatic artery infusions of FUDR, 58% had chemical hepatitis with ALT or AST >3 times ULN and mild jaundice, 8 also developed biliary strictures, and 6 of the first 19 required cholecystectomy for cholecystitis; one patient with strictures died of hepatic failure). 3971296
Botet JF, Watson RC, Kemeny N, Daly JM, Yeh S. Cholangitis complicating intraarterial chemotherapy in liver metastasis. Radiology 1985; 156: 335-7. (Among 87 patients with metastatic colorectal cancer treated with hepatic arterial infusions of FUDR, 6 developed jaundice after 2 to 9 months of therapy, with biliary strictures resembling sclerosing cholangitis [largely around the bifurcation of the common bile duct], resolving with stopping but sometimes after several weeks of progressive worsening). 3160063
Lafon PC, Reed K, Rosenthal D. Acute cholecystitis associated with hepatic arterial infusion of floxuridine. Am J Surg 1985; 150: 687-9. (Among 13 patients treated for hepatic metastases from colorectal cancer with hepatic arterial infusions of FUDR, 5 developed chemical cholecystitis [with obliterative fibrosis of the gallbladder and cystic duct] and one developed biliary strictures and jaundice, suggesting that cholecystectomy should be performed at the time of hepatectomy or pump placement). 2933968
Hohn DC, Rayner AA, Economou JS, Ignoffo RJ, Lewis BJ, Stagg RJ. Toxicities and complications of implanted pump hepatic arterial and intravenous floxuridine infusion. Cancer 1986; 57: 465-70. (Among 35 patients with hepatic metastases from colorectal cancer treated with continuous hepatic arterial infusions of FUDR, all developed liver enzyme elevations during therapy and cholangiograms in 7 showed cholangiopathy in all, usually in or around the porta hepatis). 2935242
Kemeny MM, Battifora H, Blayney DW, Cecchi G, Goldberg DA, Leong LA, Margolin KA, et al. Sclerosing cholangitis after continuous hepatic artery infusion of FUDR. Ann Surg 1985; 02: 176-81. (Among 46 patients with hepatic metastases from colorectal cancer treated with hepatic arterial infusions of FUDR, 8 [17%] developed biliary strictures, 2 to 10 months after starting chemotherapy [bilirubin 3.5-10.8 mg/dL, ALT 38-576 U/L, Alk P 460-2082 U/L], 2 of whom died). 3160313
Shepard KV, Levin B, Karl RC, Faintuch J, DuBrow RA, Hagle M, Cooper RM, et al. Therapy for metastatic colorectal cancer with hepatic artery infusion chemotherapy using a subcutaneous implanted pump. J Clin Oncol 1985; 3: 161-9. (Among 53 patients with hepatic metastases from colorectal cancer treated with continuous hepatic arterial infusions of FUDR, 26 [49%] developed ALT or AST elevations >2 times ULN, and 13 jaundice at a mean of 2.8 months after starting, resolving in all with stopping). 3155793
Pien EH, Zeman RK, Benjamin SB, Barth KH, Jaffe MH, Choyke PL, Clark LR, Paushter DM. Iatrogenic sclerosing cholangitis following hepatic arterial chemotherapy infusion. Radiology. 1985; 156: 329-30. (53 year old man with metastatic colon cancer treated with hepatic arterial infusions of FUDR for an undisclosed period developed jaundice [bilirubin "near 6" mg/dL] and biliary strictures suggestive of sclerosing cholangitis, which improved but did not completely resolve upon stopping the infusions). 3160062
Shea WJ Jr, Demas BE, Goldberg HI, Hohn DC, Ferrell LD, Kerlan RK. Sclerosing cholangitis associated with hepatic arterial FUDR chemotherapy: radiographic-histologic correlation. AJR Am J Roentgenol 1986; 146: 717-21. (Among 17 patients receiving hepatic arterial infusions of FUDR who developed cholestasis, Alk P levels were >3 times ULN in all, and cholangiography showed strictures at the bifurcation of the common bile duct with segmental involvement and none at the distal bile duct; histology showed canalicular cholestasis, ductal proliferation, and pericholangitis; autopsies showed replacement of porta hepatis with hard mass of tissue composed entirely of scar with residual portal tracts). 2937274
Doria MI Jr, Shepard KV, Levin B, Riddell RH. Liver pathology following hepatic arterial infusion chemotherapy. Hepatic toxicity with FUDR. Cancer 1986; 58: 855-61. (Hepatic histology in 8 patients with liver injury after hepatic arterial infusions of FUDR with jaundice arising after 24-95 weeks of treatment showed periductular and portal fibrosis, steatosis, mild inflammation, ductular proliferation and central vein lesions suggestive of sinusoidal obstruction syndrome). 2941140
Pettavel J, Gardiol D, Bergier N, Schnyder P. Fatal liver cirrhosis associated with long-term arterial infusion of floxuridine. Lancet 1986; 2 (8516): 1162-3. (59 year old woman with hepatic metastases due to colon cancer was treated with hepatic arterial infusions of FUDR for 27 months and had minimal serum enzyme elevations during treatment but, nevetheless, developed cirrhosis which progressed to liver failure and death). 2877311
Bolton JS, Bowen JC. Biliary sclerosis associated with hepatic artery infusion of floxuridine. Surgery 1986; 99: 119-22. (Two cases of biliary sclerosis after hepatic artery infusions with FUDR: 52 year old man and 32 year old woman developed jaundice after 3 and 2 cycles of therapy [bilirubin 17.4 and 4.0 mg/dL, ALT 1203 and 112 U/L, Alk P 1203 and 420 U/L], improving with stopping infusions with mild residual liver test abnormalities). 2934836
Anderson SD, Holley HC, Berland LL, Van Dyke JA, Stanley RJ. Causes of jaundice during hepatic artery infusion chemotherapy. Radiology 1986; 161: 439-42. (Among 176 patients with hepatic metastases treated with hepatic arterial infusions of FUDR, 94 [54%] developed jaundice [bilirubin >2.0 mg/dL], 49 of whom were analyzed further, focal or diffuse stricturing was the most common cause, and in only 3 patients was jaundice due to the metastatic liver involvement). 2945226
Laughlin EH. Common duct stricture associated with hepatic artery infusion of FUDR. J Surg Oncol 1986; 31: 56-9. (59 year old man with hepatic metastases from colon cancer developed jaundice after 34 weeks of hepatic artery infusions of FUDR [bilirubin 13.2 mg/dL], laparotomy showing stricturing at the bifurcation of the common bile duct). 2935680
Bergmann JF, Rougier P, Liguory C, Zafrani ES, Méeau JM, Dhumeaux D. [Sclerosing cholangitis after chemotherapy by continuous hepatic intra-arterial infusion of fluorodeoxyuridine]. Gastroenterol Clin Biol 1986; 10: 177-9. French. (64 year old man with hepatic metastases from colorectal cancer developed jaundice 2 months after starting hepatic arterial infusions of FUDR [bilirubin 2.7 mg/dL, ALT 1122 U/L, Alk P 795 U/L], with biliary strictures and improving after endoscopic stenting). 2939001
Pietrafitta JJ, Anderson BG, O'Brien MJ, Deckers PJ. Cholecystitis secondary to infusion chemotherapy. J Surg Oncol 1986; 31: 287-93. (39 year old woman developed chemical cholecystitis and recurrent pain during hepatic artery infusions of FUDR without biliary strictures and a shrunken, fibrotic gallbladder at surgery, later tolerating the FUDR infusions without pain). 2941626
Kemeny N, Daly J, Reichman B, Geller N, Botet J, Oderman P. Intrahepatic or systemic infusion of fluorodeoxyuridine in patients with liver metastases from colorectal carcinoma. A randomized trial. Ann Intern Med 1987; 107: 459-65. (Among 99 patients with hepatic metastases from colorectal cancer treated with 14 day courses of intravenous [iv] vs hepatic artery infusions [hai] of FUDR monthly, AST elevations occurred in 24% of iv- vs 42% of hai-treated patients, and biliary abnormalities arose in none vs 4 [9%]). 2957943
Shepard KV, Levin B, Faintuch J, Doria MI, DuBrow RA, Riddell RH. Hepatitis in patients receiving intraarterial chemotherapy for metastatic colorectal carcinoma. Am J Clin Oncol 1987; 10: 36-40. (Among 51 patients with metastatic colorectal cancer treated with hepatic arterial infusions of FUDR with either dichloromethotrexate or mitomycin C, 24 [47%] developed hepatitis 1 week to 8 months after starting therapy [bilirubin 3.0-12.5 mg/dL, ALT 26-710 U/L, mean Alk P 550 U/L]; no mention of biliary imaging or description of ultimate outcome). 2950752
Clark RA, Gallant TE. Bile duct strictures associated with hepatic arterial infusion chemotherapy. Gastrointest Radiol 1987; 12: 148-51. (Six patients with metastatic colon cancer developed biliary strictures after 3-21 months of hepatic artery infusions of FUDR [bilirubin 4 to 27 mg/dL, ALT and Alk P raised in all]; strictures were shown by CT scans or ERCP). 2951292
Ludwig J, Kim CH, Wiesner RH, Krom RA. Floxuridine-induced sclerosing cholangitis: an ischemic cholangiopathy? Hepatology 1989; 9: 215-8. (43 year old man with colorectal cancer developed jaundice after 18 months of hepatic artery infusions of FUDR [bilirubin 17.1 mg/dL, ALT 128 U/L, Alk P 630 U/L], progressing to liver failure and transplantation; explant showed sclerosing cholangitis and obliteration of arteries and small portal veins in the perihilar area, suggesting ischemia as the cause of cholangiopathy). 2521475
Andrews JC, Knol J, Wollner I, Knutsen C, Smith P, Prieskorn D, Ensminger W. Floxuridine-associated sclerosing cholangitis. A dog model. Invest Radiol 1989; 24: 47-51. (Infusion of FUDR but not saline into the hepatic artery of dogs led to rises in Alk P, ALT and bilirubin within 2-4 weeks, accompanied by strictures of the central bile ducts and attenuation of intrahepatic ducts, improving slightly but not resolving completely with stopping the infusions). 2521845
Nakhleh RE, Wesen C, Snover DC, Grage T. Venoocclusive lesions of the central veins and portal vein radicles secondary to intraarterial 5-fluoro-2'-deoxyuridine infusion. Hum Pathol 1989; 20: 1218-20. (Abstract: liver at autopsy of a patient with biliary strictures due to hepatic arterial infusions of FUDR showed changes of sinusoidal obstruction syndrome and obliteration of portal vein radicles). 2531719
Wagman LD, Kemeny MM, Leong L, Terz JJ, Hill LR, Beatty JD, Kokal WA, et al. A prospective, randomized evaluation of the treatment of colorectal cancer metastatic to the liver. J Clin Oncol 1990; 8: 1885-93. (91 patients with hepatic metastases from colorectal cancer were randomized into 6 treatment arms with FUDR; after 4-5 year follow up, 79 [87%] had died of progressive disease and 5 [5.5%] of sclerosing cholangitis). 2146370
Andrews JC, Kuntsen C, Terio P, Priescorn D, Ensminger WD. Hepatobiliary toxicity of 5-fluoro-2'-deoxyuridine. Intra-arterial versus portal venous routes of infusion. Invest Radiol 1991; 26: 461-4. (Infusion of FUDR into the portal vein of dogs resulted in ALT, Alk P and bilirubin elevations similar to that seen with hepatic artery infusions; however, no biliary strictures were seen, indicating direct toxicity to the central bile ducts rather than toxicity of a metabolite excreted in bile). 1829068
Horsmans Y, Harvengt C. [Secondary drug-induced cholestasis with bile duct involvement]. Acta Gastroenterol Belg 1991; 54: 27-33. French. (Review of the causes and mechanisms of drug induced cholestasis due to biliary injury; biliary strictures occur in 5-30% of persons who receive FUDR by hepatic artery infusion). 2058347
Pozniak MA, Babel SG, Trump DL. Complications of hepatic arterial infusion chemotherapy. Radiographics 1991; 11: 67-79. (Demonstration of radiologic features of complications of continuous hepatic artery infusions with FUDR; among 45 patients treated, 24% developed hepatitis and 7% sclerosing cholangitis). 1825358
Rougier P, Laplanche A, Huguier M, Hay JM, Ollivier JM, Escat J, Salmon R, et al. Hepatic arterial infusion of floxuridine in patients with liver metastases from colorectal carcinoma: long-term results of a prospective randomized trial. J Clin Oncol 1992; 10: 1112-8. (Among 163 patients with liver metastases from colorectal cancer randomized to receive hepatic arterial infusions of FUDR or systemic therapy, 28 of 72 [39%] treated with hepatic artery infusions developed "chemical hepatitis" and 19 [26%] sclerosing cholangitis). 1296590
Kemeny N, Seiter K, Niedzwiecki D, Chapman D, Sigurdson E, Cohen A, Botet J, et al. A randomized trial of intrahepatic infusion of fluorodeoxyuridine with dexamethasone versus fluorodeoxyuridine alone in the treatment of metastatic colorectal cancer. Cancer 1992; 69: 327-34. (Among 50 patients with metastatic colorectal cancer treated with hepatic arterial infusions of FUDR with or without dexamethasone, those given corticosteroids had lower rates of elevations in bilirubin [9% vs 30%], Alk P [57% vs 67%], AST [52% vs 57%] and of sclerosing cholangitis [0% vs 6%], as well as slightly higher response rates and survival). 1303612
Kemeny N, Huang Y, Cohen AM, Shi W, Conti JA, Brennan MF, Bertino JR, et al. Hepatic arterial infusion of chemotherapy after resection of hepatic metastases from colorectal cancer. N Engl J Med 1999; 341: 2039-48. (156 patients with hepatic metastases from colorectal cancer were treated with intravenous 5-FU and leucovorin with or without 6 cycles of hepatic arterial infusions of FUDR with dexamethasone; FUDR therapy was associated with better survival, but Alk P elevations >2 times ULN occurred in 29%, AST >3 times ULN in 65%, bilirubin >3 mg/dL in 18%, and fatal sclerosing cholangitis in 2 [3%] patients on FUDR). 10615075
Aldrighetti L, Arru M, Ronzoni M, Salvioni M, Villa E, Ferla G. Extrahepatic biliary stenoses after hepatic arterial infusion(HAI) of floxuridine(FUdR) for liver metastases from colorectal cancer. Hepatogastroenterology 2001; 48: 1302-7. (Among 54 patients treated with 9 to 19 cycles of 14 day hepatic arterial infusions of FUDR with dexamethasone, 5 [9%] developed jaundice and biliary complications [bilirubin 1.0-48 mg/dL, ALT 50-683 U/L, Alk P 428-4155 U/L], all of whom had strictures in the common bile duct and all improved with stopping therapy, with or without endoscopic or percutaneous balloon dilatation). 11677951
Barnett KT, Malafa MP. Complications of hepatic artery infusion: a review of 4580 reported cases. Int J Gastrointest Cancer 2001; 30: 147-60. (Systematic review of literature on complications of hepatic artery infusion therapy of cancer; in 23 randomized trials, mortality rate was 1% with "chemical hepatitis" in 5% using 5-FU alone vs 31% with FUDR alone, biliary toxicity in <1% vs 14%, and sclerosing cholangitis in <1% vs 12%). 12540027
Phongkitkarun S, Kobayashi S, Varavithya V, Huang X, Curley SA, Charnsangavej C. Bile duct complications of hepatic arterial infusion chemotherapy evaluated by helical CT. Clin Radiol 2005; 60: 700-9. (Among 60 patients who received hepatic arterial infusions of FUDR and were monitored every 3 months by helical CT, bile duct abnormalities were identified in 34 [57%] after 1-12 months of therapy, 10 of whom developed progressive jaundice requiring intervention). 16038698
Sandrasegaran K, Alazmi WM, Tann M, Fogel EL, McHenry L, Lehman GA. Chemotherapy-induced sclerosing cholangitis. Clin Radiol 2006; 61: 670-8. (Description of 11 patients with FUDR [n=9] or 5-FU [n=2] induced sclerosing cholangitis who underwent ERCP at a single institution; onset after 2-132 months of therapy with jaundice, pruritus or liver test abnormalities [bilirubin 0.4 to 17.6 mg/dL, Alk P 191-1106 U/L]). 16843750
Alazmi WM, McHenry L, Watkins JL, Fogel EL, Schmidt S, Sherman S, Lehman GL. Chemotherapy-induced sclerosing cholangitis: long-term response to endoscopic therapy. J Clin Gastroenterol. 2006; 40: 353-7. (Description of 11 patients with FUDR [n=9] or 5-FU [n=2] induced sclerosing cholangitis who underwent ERCP at a single institution, strictures were typically in the common hepatic duct near the bifurcation). 16633109
Bolton JS, O'Connell MJ, Mahoney MR, Farr GH Jr, Fitch TR, Maples WJ, Nagorney DM, et al. Hepatic arterial infusion and systemic chemotherapy after multiple metastasectomy in patients with colorectal carcinoma metastatic to the liver: a North Central Cancer Treatment Group (NCCTG) phase II study, 92-46-52. Clin Colorectal Cancer 2012; 11: 31-7. (Among 49 patients with complete resection of liver metastases from colorectal cancer who were treated with either FUDR or systemic chemotherapy with 5-FU and leucovorin, elevated liver enzymes occurred in 5 [14%], chemical hepatitis in 10 [28%], no mention of biliary strictures). 21729678
Ito K, Ito H, Kemeny NE, Gonen M, Allen PJ, Paty PB, Fong Y, et al. Biliary sclerosis after hepatic arterial infusion pump chemotherapy for patients with colorectal cancer liver metastasis: incidence, clinical features, and risk factors. Ann Surg Oncol 2012; 19: 1609-17. (Retrospective review of 475 patients treated with hepatic arterial infusions of chemotherapy identified 29 patients who developed jaundice which did not resolve with stopping therapy and required stenting, which was associated with higher dosing per cycle, abnormal flow scans, and postoperative infections; no patient died of biliary complications). 21989666
Ang C, Jhaveri K, Patel D, Gewirtz A, Seidman A, Kemeny N. Hepatic arterial infusion and systemic chemotherapy for breast cancer liver metastases. Breast J 2013; 19: 96-9. (Among 9 women with advanced, metastatic breast cancer, who were treated with hepatic arterial infusions of FUDR and dexamethasone combined with other systemic anticancer agents, 4 had liver enzyme elevations attributable to therapy and 3 discontinued the infusions because of liver test abnormalities). 23173748
Magge D, Choudry HA, Zeh HJ 3rd, Cunningham DE, Steel J, Holtzman MP, Jones HL, et al. Outcome analysis of a decade-long experience of isolated hepatic perfusion for unresectable liver metastases at a single institution. Ann Surg 2014; 259: 953-9. (Among 88 patients with unresectable liver metastases who underwent intrahepatic artery perusion with floxuridine at a single US referral center between 2003 and 2012, ALT elevations above 5 times ULN occurred in 44% and 5 developed "salvageable hepatic failure"). 24169176
Cercek A, D'Angelica M, Power D, Capanu M, Gewirtz A, Patel D, Allen P,et al. Floxuridine hepatic arterial infusion associated biliary toxicity is increased by concurrent administration of systemic bevacizumab. Ann Surg Oncol 2014; 21: 479-86. (Among 203 patients from 3 prospective studies of hepatic artery infusions of floxuridine with or without bevacizumab [monoclonal anti-VEGF] for hepatic metastases, liver test abnormalities and biliary stenting was required more frequently when bevacizumab was used [13% vs 0%]). 24154839
DʼAngelica MI, Correa-Gallego C, Paty PB, Cercek A, Gewirtz AN, Chou JF, Capanu M, et al. Phase II trial of hepatic artery infusional and systemic chemotherapy for patients with unresectable hepatic metastases from colorectal cancer: conversion to resection and long-term outcomes. Ann Surg 2015; 261: 353-60. (Among 49 patients with colorectal cancer who had unresectable hepatic metastases and received hepatic artery infusions of floxuridine, 23 were able to undergo successful resection of the metastases and 10 had no evidence of disease 2-5 years later; AST elevations above 5 times ULN occurred in 8 [16%] and biliary stenting was required in 4 [8%]). 24646562
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to anticancer agents, but none to floxuridine). 25754159
Chang W, Wei Y, Ren L, Zhong Y, Yu Y, Chen J, Zhu D, et al. Randomized controlled trial of intraportal chemotherapy combined with adjuvant chemotherapy (mFOLFOX6) for stage II and III colon cancer. Ann Surg 2016; 263: 434-9. (Among 237 pateints with metastatic colorectal cancer treated with folinic acid, floxuridine and oxaplatin [FOLFOX], ALT or AST elevations were more frequent in a group that also received intraoperative intraportal chemotherapy [6% vs 1%], but there were no liver related severe adverse events). 26465781
Kemeny NE, Chou JF, Boucher TM, Capanu M, DeMatteo RP, Jarnagin WR, Allen PJ, et al. Updated long-term survival for patients with metastatic colorectal cancer treated with liver resection followed by hepatic arterial infusion and systemic chemotherapy. J Surg Oncol 2016; 113: 477-84. (Long term follow up on 287 patients with colorectal cancer and liver metastases who were enrolled in 4 prospective trials of intrahepatic artery infusions of floxuridine with leucovorin, oxaliplatin or irinotecan, the overall 10 year survival was 34% and the major complication of the therapy was biliary sclerosis which occurred in 3%). 26830685

## OTHER REFERENCE LINKS

1. Recent References on Floxuridine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Floxuridine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Floxuridine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Floxuridine)